# Infertility Agents

## OVERVIEW

Infertility affects at least 10% of couples and the rate may be increasing as women in developed countries delay childbearing until later in life. The source of the infertility is primarily the woman in one-third, the man in one-third, and both in one-third of couples. Management and treatment of infertility usually begins with diagnosis of the cause. In some instances, infertility is not correctable, but in many, fertility can be corrected or improved in part by hormonal or antihormonal therapies and assisted reproductive techniques.

Anovulation in women is perhaps the single most common cause of infertility in women and can be modulated by pharmaceutical approaches. Induction of ovulation can be stimulated by antiestrogens (clomiphene, tamoxifen) or by administration or stimulation of follicle stimulating hormone (FSH) with or without luteinizing hormone (LH) and human chorionic gonadotropin (hCG). Drugs for infertility are very rare causes of drug induced liver injury, but may be associated with liver abnormalities as a part of the ovarian hyperstimulation syndrome (OHSS). The following agents are discussed in LiverTox:

- Antiestrogens
  - Clomiphene
  - Letrozole
  - Tamoxifen
- Gonadotropins
  - Human Chorionic Gonadotropin (hCG)
  - Follicle Stimulating Hormone (FSH)
  - Luteinizing Hormone (LH)
  - Gonadotropin Releasing Hormone (GnRH)

## ANNOTATED BIBLIOGRAPHY

References updated: 19 July 2017

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 555-88. (Textbook of hepatotoxicity published in 1999 mentions that clomiphene has been linked unconvincingly to one case of hepatoblastoma [in a child born to a woman who received clomiphene] and one adenoma; gonadotropins and fertility agents are not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; gonadotropins and fertility agents are not discussed).
Schimmer BP, Parker KL. Contraception and pharmacotherapy of obstetrical and gynecological disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1833-52. (Textbook of pharmacology and therapeutics).
Levin ER, Hammes SR. Estrogens and progestins. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1163-94. (Textbook of pharmacology and therapeutics).
Drugs for ovulation induction. Med Lett Drugs Ther 2011; 53 (1376): 86-8. (Concise review of the efficacy and safety of drugs used for ovarian induction mentions that common side effects of clomiphene are hot flushes, gastrointestinal upset, headache, breast discomfort and uterine bleeding. Side effects of FSH, LH and hCG include injection site reactions, headache, abdominal pain and nausea; in addition, clomiphene, FSH and LH have been linked to the ovarian hyperstimulation syndrome [OHSS] which can be severe and even fatal; no mention of ALT elevations or hepatotoxicity). 22033212